# Fruquintinib

## OVERVIEW

### Introduction

Fruquintinib is a small molecule inhibitor of vascular endothelial growth factor (VEGF) receptors that is used in adults with metastatic, heavily pretreated colorectal cancer. Fruquintinib is associated with transient elevations in serum aminotransferase during therapy and is likely to result in clinically apparent liver injury in a proportion of patients.

### Background

Fruquintinib (frue quin” tin ib) is an orally available, specific inhibitor of vascular endothelial growth factor (VEGF) receptors 1, 2 and 3 that is used in the therapy of highly refractory, metastatic colorectal cancer. VEGF receptors are frequently mutated in colorectal cancer and can account for drug resistance in therapy of metastatic colorectal cancers. Fruquintinib has activity against all three types of VEGF receptors, unlike some others which are specific for only one or two of the receptors. In two placebo controlled trials in patients with metastatic colorectal cancer who had been treated previously with multiple chemotherapeutic regimens, fruquintinib was associated with a higher rate of objective responses as well as prolongation of overall survival in comparison to placebo. Fruquintinib received accelerated approval for use in the United States in 2023. Indications were for adults with metastatic colorectal cancer after relapse or resistance to multiple, previous chemotherapies. Fruquintinib is available in capsules of 1 and 5 mg under the brand name Fruzaqla. The recommended dose regimen is 5 mg once daily in 21 day cycles every 28 days indefinitely or until intolerance or disease progression. Side effects are common with fruquintinib therapy. Common, mild-to-moderate side effects include fatigue (53%), hypertension (38%), stomatitis (31%), abdominal pain (25%), diarrhea (24%), hypothyroidism (21%), palmar-plantar erythrodysesthesia (hand-foot syndrome: 19%), proteinuria (18%), dysphonia (18%), musculoskeletal pain (16%), and arthralgia (11%). Less frequent but potentially severe adverse events include severe hypertension, hemorrhagic events, infections, gastrointestinal perforations, hand-foot syndrome, posterior reversible encephalopathy, hepatotoxicity, arterial thromboses, allergic reactions, and embryonal-fetal toxicity.

### Hepatotoxicity

In the prelicensure trials of fruquintinib, liver test abnormalities were common with its use as occurs frequently with the multikinase inhibitors. In the two large placebo controlled trials, serum ALT or AST elevations arose in 39% and 44% of fruquintinib-recipients compared to 27% and 30% of placebo-recipients. Aminotransferase levels exceeded 5 times the ULN in 6% and 4% of treated vs 3% and 2% of placebo participants. Serum aminotransferase elevations with jaundice arose only in one treated patient who developed an ALT of 270 U/L, AST 131 U/L, and a total bilirubin of 4.8 mg/dL 58 days after stopping therapy. The delay in onset was interpreted as the abnormalities being unrelated to therapy. There were no life threatening episodes of liver injury and no liver related deaths among the 1101 patients in the two controlled trials. Thus, clinically apparent liver injury was not observed with fruquintinib therapy, but ALT, AST, and bilirubin elevations were common during therapy, although not always due to the fruquintinib in these patients with advanced colorectal cancer. Furthermore, several other inhibitors of VEGF receptors have been implicated in instances of acute liver injury with symptoms and jaundice (pazopanib, regorafenib, sorafenib). Since approval and more widespread use of fruquintinib, there have been no published case reports of clinically apparent liver injury with jaundice.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations or liver injury from fruquintinib therapy are probably the result of direct toxicity of the multi-kinase receptor inhibition or related to hepatic metastases of the underlying colon cancer. Fruquintinib is metabolized in the liver largely via the CYP 3A4 pathway, and liver injury might be caused by production of a toxic or immunogenic intermediate of its metabolism. Because it is a substrate for CYP 3A4, fruquintinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

The product label for fruquintinib recommends monitoring of liver tests before initiating therapy and periodically during treatment. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to at least temporary cessation. There is no evidence to suggest a cross reactivity in risk for adverse events, hypersensitivity, or hepatic injury between fruquintinib and other VEGF receptor inhibitors such as pazopanib, regorafenib, or sorafenib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Kinase Inhibitors that Target VEGF receptors: Axitinib, Cabozantinib, Lenvatinib, Pazopanib, Regorafenib, Sorafenib, Vandetanib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fruquintinib – Fruzaqla®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fruquintinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Fruquintinib | 1194506-26-7 | C21-H19-N3-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 23 March 2025

Abbreviations: ULN, upper limit of the normal range; VEGF, vascular endothelial growth factor.

Zimmerman HJ. Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as fruquintinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not fruquintinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Mult-Discipline Review. 2023. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/217564Orig1s000TOC.cfm (FDA review of the data on efficacy and safety of fruquintinib in support of its approval for refractory, metastatic colorectal cancer in the US, mentions that liver test abnormalities were frequent in the 911 patients treated, ALT elevations arising in 34% of fruquintinib treated subjects which were above 5 times the ULN in 5%, leading to drug withdrawal in 1%, and self-limited liver injury with jaundice in one subject which arose 2 months after stopping the drug and which was judged to be unrelated to therapy).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; fruquintinib is not discussed). 23556451
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013, before the availability of fruquintinib which is not discussed). 23620168
Lu S, Chang J, Liu X, Shi J, Lu Y, Li W, Yang JJ, et al. Randomized, double-blind, placebo-controlled, multicenter phase II study of fruquintinib after two prior chemotherapy regimens in Chinese patients with advanced nonsquamous non‒small-cell lung cancer. J Clin Oncol. 2018;36:1207-1217. (Among 91 patients with advanced, refractory non-small cell lung cancer treated with fruquintinib or placebo, objective tumor responses and 6 month survival was higher with drug treatment [67% vs 59%]; no mention of hepatotoxicity or ALT elevations). 29528793
Li J, Qin S, Xu RH, Shen L, Xu J, Bai Y, Yang L, et al. Effect of fruquintinib vs placebo on overall survival in patients with previously treated metastatic colorectal cancer: the FRESCO randomized clinical trial. JAMA. 2018;319:2486-2496. (Among 416 Chinese adults with heavily pretreated, metastatic colorectal cancer treated with fruquintinib vs placebo, the overall survival rate was higher with fruquintinib [9.3 vs 6.6 months] but severe adverse events were more common [16% vs 6%] as were ALT elevations [18% vs 9%], although elevations above 5 times ULN were uncommon in both groups [0.7% vs 1.5%] and there were no life-threatening episodes or deaths from liver injury). 29946728
Dasari A, Lonardi S, Garcia-Carbonero R, Elez E, Yoshino T, Sobrero A, Yao J, et al.; FRESCO-2 Study Investigators. Fruquintinib versus placebo in patients with refractory metastatic colorectal cancer (FRESCO-2): an international, multicentre, randomised, double-blind, phase 3 study. Lancet. 2023;402(10395):41-53. (Among 934 adults with heavily pretreated, refractory metastatic colorectal treated with fruquintinib vs placebo, overall survival was higher with fruquintinib compared to placebo 7.4 vs 4.8 months, while adverse events arose in 63% vs 50% including ALT elevations in 10% vs 4% that were above 5 times ULN in 3% vs less than 1%; no mention of clinically apparent liver injury). 37331369
Fruquintinib (Fruzaqla) for metastatic colorectal cancer. Med Lett Drugs Ther. 2024;66:e34-e35. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of fruquintinib shortly after its approval for use in heavily pretreated, metastatic colorectal cancer in the US, mentions hepatotoxicity as an adverse event and the recommendation to monitor liver tests before and periodically during therapy). 38412270
Fusco MJ, Casak SJ, Mushti SL, Cheng J, Christmas BJ, Thompson MD, Fu W, et al. FDA approval summary: fruquintinib for the treatment of refractory metastatic colorectal cancer. Clin Cancer Res. 2024;30:3100-3104. (Summary of the data on efficacy and safety of fruquintinib that provided the basis for its approval as therapy of metastatic colorectal cancer, mentions that analysis of safety was based upon 1101 patients and that adverse events more frequent with fruquintinib included fatigue, hypertension, stomatitis, diarrhea, hypothyroidism, hand-foot syndrome, proteinuria, dysphonia, arthralgia, and musculoskeletal pain; no mention of ALT elevations or hepatotoxicity). 38809262

## OTHER REFERENCE LINKS

1. Recent References on Fruquintinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fruquintinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Fruquintinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fruquintinib)